# Tadalafil

## OVERVIEW

### Introcuction

Tadalafil is a selective inhibitor of phosphodiesterase type 5 (PDE5) and is used as therapy of erectile dysfunction and pulmonary hypertension. Tadalafil therapy has not been associated with serum aminotransferase elevations, but has been linked to at least one published case of clinically apparent liver injury.

### Background

Tadalafil (ta da' la fil) is a selective inhibitor of phosphodiesterase type 5 (PDE5), which mediates the breakdown of cyclic guanosine monophosphate (cGMP) inducing smooth muscle relaxation in the corpus cavernosum of the penis and in the pulmonary vasculature where this specific phosphodiesterase is found. Tadalafil is effective in prolonging erection and was approved for treatment of erectile dysfunction in the United States in 2003 and for the treatment of pulmonary hypertension and symptoms of benign prostatic hypertrophy in 2011. Tadalafil is available in tablets of 2.5, 5, 10 and 20 mg under the brand name of Cialis for erectile dysfunction and benign prostatic hyperplasia, and in 20 mg tablets under the brand name Adcirca for pulmonary hypertension. The recommended dose for erectile dysfunction is 10 mg as a single dose as needed approximately one hour before sexual activity. The dose can be increased or decreased based upon effect and tolerance, with a recommended maximum frequency of once daily and maximum dosage of 20 mg. The approved dose for pulmonary hypertension is 40 mg once daily. Common side effects include dizziness, headache, flushing, hypotension, rhinitis and dyspepsia. Rare, but potentially serious adverse events inlucding vision and hearing loss, hypotension, cardiovascular events and priapism.

### Hepatotoxicity

Despite fairly extensive use, tadalafil has been linked to only rare reports of serum aminotransferase elevations and clinically apparent liver injury. In a single case report, tadalafil was linked to cholestatic hepatitis arising within a few days of starting the medication. Immunoallergic features and autoantibodies were not present. The injury was self-limiting without residual evidence of bile duct injury. The related PDE5 inhibitor, sildenafil, has also been associated with rare cases of acute cholestatic liver injury with jaundice.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury from tadalafil is unknown, but it is metabolized in the liver via the cytochrome P450 system (CYP 3A4) and a toxic or immunogenic intermediate may account for the rare instances of hepatic injury linked to its use.

### Outcome and Management

The liver injury linked to tadalafil has been self-limited and resolving within 2 to 3 months. Tadalafil has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no known cross sensitivity between tadalafil and the other PDE5 inhibitors currently in use in the United States, but switching to another PDE5 inhibitor should be done with caution.

References to the safety and potential hepatotoxicity of tadalafil are provided in the Overview section on PDE5 Inhibitors.

Drug Class: PDE5 Inhibitors

Other Drugs in the Class: Avanafil, Sildenafil, Vardenafil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tadalafil – Cialis®

DRUG CLASS

PDE5 Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tadalafil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Tadalafil | 171596-29-5 | C22-H19-N3-O4 | Tadalafil chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Tadalafil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=tadalafil+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tadalafil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tadalafil)